# Gastrointestinal Agents

## OVERVIEW

### Introduction

Medications for gastrointestinal diseases and symptoms include prescription and nonprescription drugs, conventional and unconventional agents, simple small molecules, complex macromolecules and large recombinant proteins. These medications are can be classified based upon their use: drugs for nausea and vomiting (antiemetics), prokinetic agents, laxatives, antidiarrheal agents, drugs for acid peptic disease, drugs for irritable bowel syndrome, inflammatory bowel disease and, of course, miscellaneous. Agents used for gastrointestinal disease rarely cause liver injury. One reason for this is that they are often locally active and result in little systemic exposure. The immunomodulatory agents used to treat inflammatory bowel disease are an exception, being given systemically, often intravenously and capable of causing liver injury, although not very frequently.

Antidiarrheal agents include bulk forming agents, hydroscopic agents, bile acid resins, bismuth, inhibitors of intestinal motility, non-absorbed antibiotics and hormones. Bulk forming agents include methylcellulose; hydroscopic agents include pectin and kaolin; bile acid resins are cholestyramine, colestipol and colesevalam; inhibitors of intestinal motility include opioids such as diphenoxylate and loperamide. Antibiotics include rifamycin and rifaximin which are non-absorbed and are used for travelers' diarrhea. Hormones with antidiarrheal activity include octretide and somatostatin. Most antidiarrheal agents are active locally in the small intestine and colon and are largely not absorbed. Some, however, have been implicated in rare causes of liver injury (senna, cascara, cholestyramine). Telotristat is a relatively new agent that inhibits the synthesis of serotonin and is used specifically for the diarrhea of carcinoid syndrome. Agents discussed in LiverTox include the following, which are linked to the specific drug record:

- Bismuth
- Cholestyramine
- Colesevelam
- Colestipol
- Crofelemer
- Difenoxin
- Diphenoxylate
- Kaolin
- Loperamide
- Methylcellulose
- Octreotide
- Pectin
- Rifamycin
- Rifaximin
- Somatostatin
- Telotristat

Antiemetics are a diverse group of medications that act at different points in the pathways that regulate nausea and vomiting. These include antihistamines, anticholinergic agents, phenothiazines, serotonin type 3 receptor blockers, centrally acting benzamides, cannabinoid receptor agonists, substance P antagonists and miscellaneous. Agents discussed in LiverTox include the following, which have links to the specific drug record:

- Anticholinergic Agents
  - Hyoscyamine, Methscopolamine, Scopolamine
- Antihistamines
  - Cyclizine, Dimenhydrinate, Hydroxyzine, Meclizine, Promethazine
- Cannabinoid Receptor Agonists
  - Dronabinol, Nabilone, Tetrahydrocannabinol
- Phenothiazines [See Antipsychotic Agents]
  - Chlorpromazine, Prochlorperazine
- Serotonin 5-HT3 Receptor Antagonists
  - Alosetron, Dolasetron, Granisetron, Ondansetron, Palonosetron
- Substance P/Neurokinin 1 Receptor Antagonists
  - Aprepitant, Fosaprepitant, Fosnetupitant, Rolapitant
- Miscellaneous
  - Amisulpride, Dexamethasone, Metoclopramide, Trimethobenzamide

Acid peptic disease/antiulcer agents that include antacids, the histamine type 2 receptor blockers (H2 blockers), and the proton pump inhibitors (PPIs). These agents are some of the most commonly taken medications and are very well tolerated, most being available both by prescription and over-the-counter. While many of these drugs are approved for use in duodenal and gastric ulcer disease, their major use is for acid reflux and indigestion. Agents discussed in LiverTox include the following, which are linked to the specific drug record:

- Histamine H2 Receptor Antagonists (H2 Blockers)
  - Cimetidine, Famotidine, Nizatidine, Ranitidine
- Proton Pump Inhibitors
  - Dexlansoprazole, Esomeprazole, Lansoprazole, Omeprazole, Pantoprazole, Rabeprazole

Cathartics, laxatives or agents for constipation include bulk forming agents, osmotic agents, stool wetting agents, nonspecific stimulants, prokinetic agents and agents that increase fluid secretion. Many of these therapies are not systemically absorbed and none are considered particularly hepatotoxic. Naldemedine and naloxegol are opioid antagonists and are used to treat the constipation associated with opioid use. Not all of these agents are discussed in LiverTox, but those that are have links to the specific drug record:

- Bisacodyl
- Cascara Sagrada
- Castor Oil
- Docusate
- Fiber, Bran
- Lactulose
- Magnesium Sulfate
- Methylcellulose
- Naldemedine (Opioid Antagonist)
- Naloxegol (Opioid Antagonist)
- Plecanatide (for Chronic Idiopathic Constipation)
- Prucalopride (for Chronic Idiopathic Constipation)
- Senna

Inflammatory bowel disease encompasses several disorders, most commonly ulcerative colitis and Crohn colitis. Agents can be classified as 5-aminosalicyclic acid (5-ASA) based agents, immunosuppressive drugs, antitumor necrosis factor agents, corticosteroids, antibiotics and miscellaneous. Agents discussed in LiverTox include the following, which are linked to the specific drug record:

- 5-Aminosalicyclic Acid (5-ASA) Derivatives
  - Balsalazide, Mesalamine, Olsalazine, Sulfasalazine
- Immunosuppressive Agents
  - Azathioprine, Mercaptopurine, Methotrexate
- Tumor Necrosis Factor Antagonists
  - Adalimumab, Certolizumab, Golimumab, Infliximab
- Miscellaneous
  - Metronidazole, Natalizumab, Vedolizumab

Irritable bowel syndrome or functional bowel disease is a common, but not well understood syndrome or collection of symptoms marked by variable degrees of diarrhea and constipation with abdominal bloating and pain. Symptomatic therapies with antidiarrheal agents, drugs for constipation, analgesics, prokinetic agents or antispasmotics are often applied. Medications developed specifically for irritable bowel syndrome include agents that affect specific gastrointestinal receptors or hormones and include tegaserod, alosetron, linaclotide, plecanatide, prucalopride, and lubiprostone. None of these agents, however, is particularly hepatotoxic. Eluxadoline is a unique agent that is used to treat diarrhea-predominant irritable bowel syndrome. It is a mixed opioid receptor agonist (mu) and antagonist (delta) and can cause spasm of the sphincter of Oddi and pancreatitis accompaniend by marked serum aminotransferase elevations. Linaclotide and plecanatide are guanylate cyclase C receptor agonists and are used to treat chronic idiopathic constipation or "constipation predominant" irritable bowel syndrome. Similarly, cisapride, prucalopride and tegaserod are serotonin type 4 receptor agonists that are used for chronic idiopathic constipation. Agents discussed in LiverTox include the following, which are linked to the specific drug record:

- Antimuscarinics/Antispasmodics [See Anticholinergic Agents]
  - Dicyclomine, Glycopyrrolate, Hyoscyamine, Methscopolamine
- Prokinetic Agents [See Serotonin 5-HT4 Receptor Agonists]
  - Alosetron, Cisapride, Domperidone, Linaclotide, Lubiprostone, Metoclopramide, Plecanatide, Prucalopride, Tegaserod
- Opioid receptor mixed agonist/antagonist; Other
  - Eluxadoline, Tenapanor

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2019

Zimmerman HJ. H1 Receptor antagonists. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 717-8. (Single author review of hepatotoxicity published in 1999).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of drugs for inflammatory bowel disease).
Sharkey KA, MacNaughton WK. Pharmacotherapy for gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 909-20. (Textbook of pharmacology and therapeutics).
Sharkey KA, MacNaughton WK. Gastroinestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).